# Mexiletine

## OVERVIEW

### Introduction

Mexiletine is an oral antiarrhythmic agent that is used for suppression of ventricular arrhythmias. Long term mexiletine therapy is associated with a low rate of serum enzyme elevations and is a rare cause of clinically apparent acute liver injury.

### Background

Mexiletine (mex il' e teen) is an analogue of the local anesthetic lidocaine and has electrophysiological effects that resemble quinidine (antiarrhythmic Class IB). Mexiletine appears to act by blocking open sodium channels and outward potassium channels. As a consequence, it decreases cardiac automaticity, increases refractory periods and slows conduction. Mexiletine was approved for use in the United States in 1985, and current indications include suppression of life threatening ventricular arrhythmias including ventricular tachycardia. It is also used off-label to treat neuropathy. Mexiletine is available in capsules of 150, 200 and 250 mg generically and under the brand name Mexitil. The usual maintenance dose in adults is 200 to 300 mg every 6 hours. The dosage used to treat neuropathy is typically 300 mg daily. The most common side effects include gastrointestinal upset, nausea, dizziness, anxiety, tremor, blurred vision and skin rash. Uncommon but potentially severe adverse events include worsening of arrhythmias and congestive heart failure, blood dyscrasias and hypersensitivity reactions, including Stevens Johnson syndrome.

### Hepatotoxicity

In clinical trials, mexiletine was associated with a low rate of serum aminotransferase and alkaline phosphatase elevations (~0.5%). Despite wide scale use, mexiletine has only rarely been linked to cases of clinically apparent liver injury. Most cases are associated with a hypersensitivity reaction. Typically, patients present with fever, rash, eosinophilia and systemic systemics (DRESS syndrome) after 2 to 6 weeks of mexiletine therapy. Eosinophilia or atypical lymphocytosis usually accompany the liver test abnormalities but may arise or continue to worsen days or weeks after onset. The pattern of serum enzyme elevations ranges from cholestatic to hepatocellular, but jaundice is usually mild or absent. Autoimmune features are uncommon. Cases of Stevens Johnson and DRESS syndrome due to mexiletine have also been reported. Corticosteroids were often used, but largely for the fever and skin rash rather than the liver disease which was typically mild. Rare instances of cholestatic hepatitis with mexiletine therapy have also been reported and may represent a different form of liver injury.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury from mexiletine appears to be mediated by a hypersensitivity reaction. Mexiletine is metabolized in the liver by the cytochrome P450 system and an immunoallergic metabolite may be produced. The hypersensitivity reaction to mexiletine may be more common in Asian than other populations.

### Outcome and Management

The liver injury due to mexiletine is usually overshadowed by the signs and symptoms of hypersensitivity. No cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to mexiletine have been reported. The signs and symptoms of hypersensitivity typically respond rapidly to corticosteroid therapy, but it is unclear whether the liver injury is similarly affected by the immunosuppression and many cases resolve rapidly without systemic corticosteroid therapy. There have been no reports of cross sensitivity to the liver injury between mexiletine and other oral antiarrhythmics, but shared sensitivity is unlikely.

Drug Class: Antiarrhythmic Agents

## CASE REPORT

### Case 1. Drug rash with eosinophilia and liver injury attributed to mexiletine.(1)

A 64 year old man developed rash and fever 30 days after starting mexiletine (100 mg three times daily) for a painful, postherpetic neuropathy. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. His other medications included amitriptyline (125 mg daily) and alprazolam (0.4 mg three times daily) which he had taken for the previous 2 years. On examination, the temperature was 38.3 ^o^C. He had a morbilliform skin rash involving the face and trunk, but was not jaundiced. Laboratory tests showed a normal white count (7,300/μL) with 3% eosinophils and 1% atypical lymphocytes. Serum aminotransferase (ALT 252 U/L and AST 235 U/L) and alkaline phosphatase levels (574 U/L) were both elevated, but bilirubin was normal (0.7 mg/dL) (Table). His medications were stopped, but during the next week the rash worsened and he developed a marked eosinophilia (10.5%), atypical lymphocytosis (9.5%) and jaundice (Table). He was treated with dexamethasone (8 mg daily), followed by rapidly tapering doses of oral prednisolone. The fever and the rash improved, disappearing within 4 weeks. Jaundice also resolved rapidly, but serum alkaline phosphatase decreased more slowly and was still slightly elevated 7 weeks after stopping mexiletine. Amitriptyline was resumed at a higher dose without recurrence of jaundice or rash.

#### Key Points

Medication: | Mexiletine (100 mg three times a day)
Pattern: | Mixed-cholestatic (R=2.2, falling to 1.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 30 days to rash, 38 to jaundice
Recovery: | Incomplete at 6 weeks
Other medications: | Amitriptyline, alprazolam

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 36 | 239 | 0.4
30 | 0 | 252 | 574 | 0.7
38 | 0 | 317 | 1280 | 3.7 | Corticosteroids started
50 | 12 | 194 | 700 | 1.3 | Eosinophils 51%
60 | 22 | 69 | 767 | 0.8
71 | 33 | 36 | 535 | 0.5 | Amitriptyline resumed
Normal Values | | <40 | <290 | <1.2

#### Comment

The clinical presentation was typical of DRESS syndrome (drug rash with eosinophilia and systemic symptoms) such as occurs with the aromatic anticonvulsants and allopurinol. Rash is not an uncommon side effect of mexiletine, but liver injury and jaundice are rare. The cause is likely hypersensitivity, and corticosteroids are often used with an immediate effect on fever and skin rash. Whether the liver injury is improved by corticosteroid therapy is unclear. In this publication, long term follow up information was not provided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mexiletine – Generic, Mexitil®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mexiletine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mexiletine | 31828-71-4 | C11-H17-N-O

## CITED REFERENCE

1 Higa K, Hirata K, Dan K. (1997). Mexiletine-induced severe skin eruption, fever, eosinophilia, atypical lymphocytosis, and liver dysfunction. Pain.

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2020

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics published in 1999; mentions that mexiletine has been linked to 6 cases of clinically apparent liver injury).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of cardiovascular drugs including antiarrhythmics mentions that mexiletine has been linked to cases of cholestatic hepatitis).
Knollmann BC, Roden DM. Antiarrhythmic drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 547-72. (Textbook of pharmacology and therapeutics).
Campbell NP, Pantridge JF, Adgey AA. (1978). Long-term oral antiarrhythmic therapy with mexiletine. Br Heart J. (48 patients treated with mexiletine long term, found side effects were common but no mention of liver injury or ALT elevations).
Pernot C, Netter P, Marcon F, Weber JL. (1983). Presse Med. (48 year old man developed asymptomatic ALT elevations 15 days after starting mexiletine, but they decreased and drug was continued to 3 months when ALT rose to 1030 U/L, GGT 265 U/L, bilirubin 1.1 mg/dL, falling towards normal over next 4 months after stopping).
Geisler C, Keiding S. (1984). Ugeskr Laeger.
Dejgard A, Petersen P, Kastrup J. (1988). Mexiletine for treatment of chronic painful diabetic neuropathy. Lancet. (Cross over, double blind trial of 26 weeks of mexiletine for diabetic neuropathy; no mention of ALT levels).
Higa K, Hirata K, Dan K. (1997). Mexiletine-induced severe skin eruption, fever, eosinophilia, atypical lymphocytosis, and liver dysfunction. Pain. (64 year old man developed jaundice, fever and rash 30 days after starting mexiletine [bilirubin 3.7 mg/dL, ALT 242 U/L, Alk P 1280 U/L, 51% eosinophilia, 9% atypical lymphocytes], resolving with corticosteroid therapy in 4 weeks: Case 1).
Roden DM. (2000). Antiarrhythmic drugs: from mechanisms to clinical practice. Heart. (Overview of antiarrhythmic drugs which are separated in four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers; and, IV calcium channel blockers; and, some agents having multiple targets).
Sasaki K, Yamamoto T, Kishi M, Yokozeki H, Nishioka K. (2001). Acute exanthematous pustular drug eruption induced by mexiletine. Eur J Dermatol. (56 year old man developed rash 1 month after starting mexiletine [ALT 129 U/L, bilirubin and Alk P not given, eosinophils 20%], resolving within 3 months of stopping).
Seino Y, Yamauchi M, Hirai C, Okumura A, Kondo K, Yamamoto M, Okazaki Y. (2004). A case of fulminant Type 1 diabetes associated with mexiletine hypersensitivity syndrome. Diabet Med. (46 year old man developed rash 41 days after starting mexiletine for diabetic neuropathy [ALT 66 rising to ~720 U/L, bilirubin and Alk P not given], resolving with corticosteroid therapy with worsening of diabetes).
Sekiguchi A, Kashiwagi T, Ishida-Yamamoto A, Takahashi H, Hashimoto Y, Kimura H, Tohyama M, et al. (2005). Drug-induced hypersensitivity syndrome due to mexiletine associated with human herpes virus 6 and cytomegalovirus reactivation. J Dermatol. (66 year old man developed fever and rash with ALT elevations one month after starting mexiletine with progressive course, and HHV-6 and CMV present in serum, and death from myocarditis).
Yagami A, Yoshikawa T, Asano Y, Koie S, Shiohara T, Matsunaga K. (2006). Drug-induced hypersensitivity syndrome due to mexiletine hydrochloride associated with reactivation of human herpesvirus 7. Dermatology. (44 year old developed rash, fever and mononucleosis-like syndrome 6 months after starting mexiletine [ALT 144 U/L, atypical lymphocytes 15%, bilirubin and Alk P not given], with presence of human herpesvirus-7 DNA in white cells and skin; treated with prednisolone and resolved in 2-3 months).
(2007). Drugs for cardiac arrhythmias. Treat Guidel Med Lett. (Concise review of drugs for arrhythmias; mexiletine is an orally effective congener of lidocaine and is used as an alternative to amiodarone for ventricular arrhythmias; mentions hepatitis as an adverse event).
Lee SP, Kim SH, Kim TH, Sohn JW, Shin DH, Park SS, Yoon HJ. (2010). A case of mexiletine-induced hypersensitivity syndrome presenting as eosinophilic pneumonia. J Korean Med Sci. (82 year old man developed cough, fever and rash 6 months after starting mexiletine [ALT 321 U/L, bilirubin and Alk P not given, eosinophils 24%], eosinophilic pneumonitis on lung biopsy, resolving with prednisone therapy within 2 months of stopping).
Statland JM, Bundy BN, Wang Y, Rayan DR, Trivedi JR, Sansone VA, Salajegheh MK, et al., Consortium for Clinical Investigation of Neurologic Channelopathies. (2012). Mexiletine for symptoms and signs of myotonia in nondystrophic myotonia: a randomized controlled trial. JAMA. (Among 59 patients with nondystrophic myotonia treated with mexiletine [200 mg] or placebo 3 times daily for 4 weeks followed by cross-over, side effects included gastrointestinal discomfort and there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
Uhara H, Saiki M, Kawachi S, Ashida A, Oguchi S, Okuyama R. (2013). Clinical course of drug-induced hypersensitivity syndrome treated without systemic corticosteroids. J Eur Acad Dermatol Venereol. (Among 12 patients with drug induced hypersensitivity syndrome, all recovered including one case due to mexiletine; a 70 year old man with post-herpetic neuropathy who developed fever, rash, eosinophilia and ALT elevations [239 U/L] 34 days after starting mexiletine, and recovered without corticosteroid therapy in 37 days).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to mexiletine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none of which were attributed to mexiletine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to antiarrhythmics, but none to mexiletine).
Suetterlin KJ, Bugiardini E, Kaski JP, Morrow JM, Matthews E, Hanna MG, Fialho D. (2015). Long-term safety and efficacy of mexiletine for patients with skeletal muscle channelopathies. JAMA Neurol. (Among 63 patients with myotonia treated with mexiletine for up to 17.8 years [mean 4.8 years], there were no serious adverse events but dyspepsia was common and led to discontinuation in 4 patients; no mention of ALT elevations or hepatotoxicity).
Shibuya K, Misawa S, Kimura H, Noto Y, Sato Y, Sekiguchi Y, Iwai Y, et al. (2015). A single blind randomized controlled clinical trial of mexiletine in amyotrophic lateral sclerosis: efficacy and safety of sodium channel blocker phase II trial. Amyotroph Lateral Scler Frontotemporal Degener. (Among 60 patients with amyotrophic lateral sclerosis treated with riluzole with or without mexiletine [300 mg daily] for 6 months, adverse events were more frequent in those receiving mexiletine but there were no serious adverse events and only one case of “liver dysfunction” which occurred in a riluzole only treated subject).
Weiss MD, Macklin EA, Simmons Z, Knox AS, Greenblatt DJ, Atassi N, Graves M, et al., Mexiletine ALS Study Group. (2016). A randomized trial of mexiletine in ALS: Safety and effects on muscle cramps and progression. Neurology. (Among 60 patients with amyotrophic lateral sclerosis treated with mexiletine [300 or 900 mg daily] or placebo for 12 weeks, adverse events and discontinuations were common with the higher dose of mexiletine and muscle cramps were less; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Mexiletine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mexiletine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mexiletine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mexiletine)